# Betaxolol

## OVERVIEW

### Introduction

Betaxolol is a cardioselective beta-blocker used in the treatment of hypertension. Betaxolol has not been linked to instances of clinically apparent drug induced liver injury.

### Background

Betaxolol (be tax' oh lol) is considered a “selective” beta-adrenergic receptor blocker in that it has potent activity against beta-1 adrenergic receptors which are found in cardiac muscle, but has little or no activity against beta-2 adrenergic receptors found on bronchial and vascular smooth muscle. Betaxolol was approved for use in the United States in 1985 and is currently used mostly in the therapy of hypertension in combination with other agents. Betaxolol is available in 10 and 20 mg tablets in generic forms as well as under the trade name of Kerlone. Liquid ophthalmic solutions of betaxolol and its stereoisomer levobetaxolol are available for use in ocular hypertension and glaucoma. The usual initial oral dose of betaxolol in adults is 10 mg once daily, with subsequent adjustment based upon clinical response and tolerance; the usual maintenance dosage being 10 to 40 mg daily. Common side effects include bradycardia, hypotension, fatigue, dizziness, depression, insomnia, memory loss and impotence. At high doses, betaxolol is less cardioselective and can induce bronchospasm. As with all beta-blockers, sudden withdrawal can trigger rebound hypertension.

### Hepatotoxicity

Betaxolol therapy has been associated with a low rate of mild-to-moderate elevations of serum aminotransferase levels which are usually asymptomatic and transient and resolve even with continuation of therapy. There have been no well documented cases of clinically apparent, acute liver injury attributable to betaxolol. Thus, hepatotoxicity due to betaxolol must be very rare, if it occurs at all. Most commonly used beta-blockers have been linked to rare instances of clinically apparent liver injury, typically with onset within 2 to 12 weeks, a hepatocellular pattern of liver enzyme elevations, rapid recovery on withdrawal, and little evidence of hypersensitivity (rash, fever, eosinophilia) or autoantibody formation.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of drug induced liver injury from beta-blockers such as betaxolol is not known. Betaxolol is extensively metabolized by the liver and excreted as inactive metabolites. The few cases of acute liver injury attributed to beta-blockers were likely idiosyncratic.

### Outcome and Management

The severity of liver injury due to beta-blockers ranges from mild serum aminotransferase elevations to acute hepatitis with jaundice. In large case series of drug induced liver injury and acute liver failure due to medications, betaxolol has not been listed as a potential cause. There is little information about cross reactivity among the beta-blockers to hepatic injury. Switching from a beta-blocker that has caused acute liver injury to another should be done with caution and active monitoring.

References to the safety and potential hepatotoxicity of betaxolol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated in June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Betaxolol – Generic, Kerlone®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=betaxolol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Betaxolol | 63659-18-7 | C18-H29-N-O3 | Betaxolol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Betaxolol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Betaxolol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Betaxolol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Betaxolol)